# Sulfonylureas, Second Generation

## OVERVIEW

### Introduction

The second generation sulfonylureas include glyburide (also known as glibenclamide), gliclazide, glipizide, and glimepiride, which are oral hypoglycemic agents that are widely used in therapy of type 2 diabetes. These agents are known, but infrequent causes of clinically apparent liver injury.

### Background

The sulfonylureas are substituted arylsulfonylureas, their differences being in the types of substitutions at the two ends of the molecule. The sulfonylureas lower blood glucose through an increase in secretion of insulin from pancreatic beta cells. They may also have other extra-pancreatic hypoglycemic actions that are important during prolonged therapy. The second generation sulfonylureas have largely replaced the first generation agents in routine use, because they are more potent, can be administered in lower doses, and can be given on a once daily basis. These agents are recommended as a first line of therapy for type 2 diabetes, but should be administered in conjunction with advice on diet and exercise. The sulfonylureas can also be used in combination with other hypoglycemic agents such as metformin, pioglitazone, alpha glucosidase inhibitors, incretin based drugs or insulin. Because of the similarity of mechanism of action, the sulfonylureas are not recommended to be used in combination with the metiglinides such as nateglinide and repaglinide. Common side effects of the second generation sulfonylureas include headache, dizziness, paresthesias, abdominal discomfort, nausea and weight gain. These agents are also associated with an “antabuse” like response to alcohol (although less likely that with first generation sulfonylureas) and patients should be advised not to drink alcoholic beverages. All sulfonylureas can cause hypoglycemia. The second generation sulfonylureas are all labelled with a special warning about increased risk for cardiovascular mortality.

Glyburide (glye' bure ide), which is known in other countries as glibenclamide, is available in generic forms and under the brand name of DiaBeta and Micronase in tablets of 1.25, 2.5 and 5 mg, the recommended dose initially being 1.25 to 5 mg daily, with increases based upon blood glucose and tolerance to a maximum of 20 mg daily, either in a single or divided dose. Micronized formulations are also available in tablets of 1.5, 3 and 6 mg, that may provide more sustained release. Fixed combinations of glyburide with metformin are also available in many generic forms and under the commercial name Glucovance.

Gliclazide is available in generic forms and under the brand name of Diamicron and Dianorm in many countries, but not in the United States. The recommended dose initially is 40 to 80 mg twice daily, with increases weekly to achieve adequate glycemic control. The maximum dose is 320 mg daily.

Glimepiride (glye mep' ir ide) is available under in several generic forms and the brand name of Amaryl in tablets of 1, 2 and 4 mg, the recommended dose initially being 1 to 2 mg once daily, with increases based upon blood glucose and tolerance to a maximum of 8 mg once daily. Fixed dose combinations of glimepiride with thiazolidinediones have also been marketed (with rosiglitazone as Avandaryl, and with pioglitazone as Duetact).

Glipizide (glip' i zide) is available in multiple generic forms and under the brand name of Glucotrol in tablets of 5 and 10 mg and as an extended release form (Glucotrol XL) in 2.5, 5 and 10 mg, the recommended dose initially being 5 to 10 mg daily, with increases based upon blood glucose and tolerance to a maximum of 15 mg (standard formulation) or 20 mg (extended release formulation) once daily. Higher doses should be given in divided doses daily to a daily maximum of 40 mg. Fixed combinations of glipizide with metformin are also available in both generic and brand name forms (Metaglip).

### Hepatotoxicity

Minor enzyme elevations have been reported to occur during sulfonylurea therapy in less than 1% of patients, rates that are similar to what occurs with placebo therapy. Clinically apparent liver injury from the sulfonylureas is rare, but has been reported for virtually all of the currently available forms and appears to be a class effect. The liver injury appears within 3 to 12 weeks of starting the medication, usually with symptoms of fatigue, nausea and abdominal discomfort, followed by dark urine and jaundice. Rare instances of hepatic injury arising after many months or years of therapy have been reported, particularly soon after an increase in dosage. Various combinations of hepatocellular and cholestatic injury have been described with sulfonylurea induced liver injury, and many cases are reported to be mixed. Allergic manifestations can occur, but are not typical and autoantibody formation is rare. Because sulfonylureas are usually given in combination with other hypoglycemic agents, many of which also cause liver injury, it can be difficult to establish whether the injury is due to the sulfonylurea or another agent. The timing of injury in relationship to starting the medication is perhaps most characteristic feature. Recovery is usually rapid once the medication is stopped. While all of the second generation sulfonylureas have been linked to cases of clinically apparent liver injury, the most cases have been associated with glyburide (referred to as glibenclamide outside of the United States), perhaps because it has been the most widely used.

Glyburide likelihood score: B (likely rare cause of clinically apparent liver injury).

Gliclazide likelihood score: D (possible cause of clinically apparent liver injury).

Glimepiride likelihood score: C (probable cause of clinically apparent liver injury).

Glipizide likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to sulfonylureas is unknown, but suspected to be due to hypersensitivity. Cross reactivity to reactions to sulfonamides can occur, but not invariably and the overall pattern of injury and outcome of sulfonylurea associated hepatic injury does not resemble the acute, immunoallergic pattern that is common with the sulfonamides. Nevertheless, the sulfonylureas should be used with caution in patients with sulfonamide hypersensitivity or a history of sulfonamide-hepatotoxicity. In either case, rechallenge usually leads to recurrence and should be avoided.

### Outcome and Management

The liver injury from the sulfonylureas usually resolves rapidly once the agent is stopped, but chronic injury has been described in rare cases. Despite the usual cholestatic form of injury, cases of progressive hepatic failure and death have been described, particularly in the elderly or patients with multiple other medical problems and when the medication is not promptly withdrawn. Sulfonylureas are rarely listed in causes of acute liver failure due to medications. In cases in which multiple hypoglycemic agents were being used when the liver injury appears, rechallenge with the agent least likely associated with the injury is appropriate.

References to the second generation sulfonylureas and examples of hepatotoxicity are given in the Overview section on the Sulfonylureas (updated March 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Sulfonylureas: First Generation Sulfonylureas

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gliclazide – Diamicron®

Glimepiride – Amaryl®

Glipizide – Glucotrol®

Glyburide – Diabeta®, Micronase®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gliclazide | 21187-98-4 | C15-H21-N3-O3-S | Gliclazide chemical structure
Glimepiride | 93479-97-1 | C24-H34-N4-O5-S | Glimepiride chemical structure
Glipizide | 29094-61-9 | C21-H27-N5-O4-S | Glipizide chemical structure
Glyburide | 10238-21-8 | C23-H28-Cl-N3-O5-S | Glyburide chemical structure